# Vibegron

## OVERVIEW

### Introduction

Vibegron is an orally available beta-3 adrenergic receptor agonist that is used to treat symptoms of overactive bladder of urgency, frequency, and incontinence in adults. As with most beta-adrenergic agonists, vibegron has not been associated with serum aminotransferase or alkaline phosphatase elevations during therapy, and clinically apparent liver injury has not been reported with its use.

### Background

Vibegron (vye beg’ ron) is a selective beta-3 adrenergic receptor agonist used for the treatment of symptoms of urgency, frequency, and incontinence in adults with overactive bladder syndrome. Beta adrenergic receptor agonists decrease smooth muscle tone and beta-3 selective agents have maximal effects on the bladder, causing relaxation of the detrusor muscle which increases bladder capacity thus decreasing urinary frequency and urgency. In prospective, controlled trials, vibregron was associated with a modest increase in bladder capacity and decrease in daily micturitions in adults with symptomatic overactive bladder syndrome. Vibegron was approved in the United States in 2020 but has not been widely used. Vibegron is available in tablets 75 mg under the brand name Gemtesa. The recommended dose for adults is 75 mg daily. Vibegron is generally well tolerated, the most common significant adverse effect being urinary retention. Uncommon side effects (less than 2% of patients) may include headache, diarrhea, nausea, dry mouth, pruritus, and constipation. Rare potentially severe adverse events include rash and embryo-fetal toxicity.

### Hepatotoxicity

Vibegron, like other beta-adrenergic agents, is rarely associated with serum ALT or alkaline phosphatase elevations. In large randomized, placebo-controlled trials, serum aminotransferase elevations arose in less than 1% of treated participants, rates that were similar to patients receiving placebo and comparator agents such as tolterodine. In the registration trials of vibegron and since its approval and more widescale use, there have been no reports of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Vibegron undergoes minimal metabolism by the liver and has no important drug-drug inactions with inducers or inhibitors of cytochrome P450 enzymes. The potential mechanism of liver injury from vibegron and other beta-adrenergic receptor agonists is unknown.

Drug Class: Urologic Agents, Overactive Bladder Syndrome Agents

Other Drugs in the Subclass, Overactive Bladder Syndrome Agents: Darifenacin, Fesoterodine, Flavoxate, Hyoscyamine, Mirabegron, Oxybutynin, Solifenacin, Tolterodine, Trospium

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vibegron – Gemtesa®

DRUG CLASS

Urologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vibegron)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Vibegron | 1190389-15-1 | C26-H28-N4-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 10 July 2023

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of drug induced liver injury published in 1999 before the availability of beta-3 adrenergic receptor agonists and other drugs for overactive bladder syndrome such as tolterodine, mirabegron or vibegron).
Westfall TC, Macarthur H, Westfall DP. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 191-223. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213006Orig1s000MedR.pdf (FDA website with product labels and FDA review of the safety and efficacy of vibegron based upon submission of data by the sponsor in support of its approval, mentions that in a large preregistration trial, ALT elevations above 3 times the upper limit of normal arose in 0.2% of 545 patients on vibegron and 0.3% of 540 receiving placebo, and there were no cases of liver test abnormalities accompanied by symptoms or jaundice and no hepatic serious adverse events).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to mirabegron or vibegron). 20949552
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to urologic agent such as mirabegron, vibegron, or tolterodine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to a urologic agent such as mirabegron, vibegron or tolterodine). 25754159
Thiagamoorthy G, Cardozo L, Srikrishna S. Drug therapy for an overactive bladder. Womens Health (Lond) 2015; 11: 445-8. (Overactive bladder is defined as urinary urgency, usually with frequency and nocturia with or without incontinence in the absence of infection or other known cause, medical therapy being use of anticholinergics or beta-3 adrenergic receptor agonists such as mirabegron or vibegron which have fewer side effects than typical anticholinergics). 26238677
Edmondson SD, Zhu C, Kar NF, Di Salvo J, Nagabukuro H, Sacre-Salem B, Dingley K, et al. Discovery of vibegron: a potent and selective β3 adrenergic receptor agonist for the treatment of overactive bladder. J Med Chem. 2016;59:609-23. (Description of the development of a selective beta-2 adrenergic receptor agonist with in vitro activity against bladder smooth muscle and no structural evidence for hepatic toxicity [phospholipidosis]). 26709102
Staskin D, Frankel J, Varano S, Shortino D, Jankowich R, Mudd PN Jr. International phase III, randomized, double-blind, placebo and active controlled study to evaluate the safety and efficacy of vibegron in patients with symptoms of overactive bladder: EMPOWUR. J Urol. 2020;204:316-324. (Among 1518 adults with overactive bladder treated with vibegron [75 mg], tolterodine [4 mg], or placebo once daily for 12 weeks, daily micturitions decreased by 1.8 episodes with the two medications vs 1.4 with placebo, while adverse events were uncommon [39% and 39% vs 33%] and ALT elevations were rare [0.2% and 0.2% vs 0.4%] and there were no hepatic severe adverse events or discontinuations). 32068484
Vibegron (Gemtesa) for overactive bladder. Med Lett Drugs Ther. 2021;63(1623):67-69. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of vibegron shortly after its approval for use in the US, mentions adverse events of headache and nasopharyngitis, but urinary retention was uncommon [0.6% vs 0.4% with placebo]; no mention of ALT elevations or hepatotoxicity). 33976098
Staskin D, Frankel J, Varano S, Shortino D, Jankowich R, Mudd PN Jr. Once-daily vibegron 75 mg for overactive bladder: long-term safety and efficacy from a double-blind extension study of the international phase 3 trial (EMPOWUR). J Urol. 2021;205:1421-1429. (Among 506 patients completing the 12-week placebo-controlled trial of vibegron [Staskin 2020] who were continued on vibegron or tolterodine to week 52, improvements in numbers of micturitions and incontinence and urgency episodes were slightly greater with vibegron, while adverse event rates were similar and “changes in clinical laboratory parameters…were not considered clinically meaningful.”). 33356445
Lacy BE, King J, Shortino D, Schaumburg C, Haag-Molkenteller C, Chey WD. Efficacy and safety of vibegron for the treatment of irritable bowel syndrome in women: Results of a randomized, double-blind, placebo-controlled phase 2 trial. Neurogastroenterol Motil. 2022;34(12):e14448. (Among 222 adult women with diarrhea-predominant irritable bowel syndrome treated with vibegron [75 mg] or placebo once daily for 12 weeks, rates of improvements in abdominal pain and diarrhea were similar in the two groups as were overall adverse event rates [33% in both]; no mention of ALT elevations but there were no hepatic serious adverse events). 35975404
Kinjo M, Masuda K, Nakamura Y, Miyakawa J, Tambo M, Fukuhara H. Comparison of mirabegron and vibegron in women with treatment-naive overactive bladder: A randomized controlled study. Urology. 2023;175:67-73. (Among 199 adult women with overactive bladder syndrome treated with 50 mg of either mirabegron or vibegron daily for 12 weeks, response rates were similar in both groups as were overall rates of adverse event [17.5% vs 15.7%], discontinuations [6.2% vs 6.8%], constipation [10.3% vs 11.8%], dry mouth [both 1%], and rash [2% vs 1%]; no mention of ALT elevations or hepatotoxicity). 36822245
Drugs for overactive bladder. Med Lett Drugs Ther. 2023;65:41-45. (Concise review of drugs approved for therapy of overactive bladder in the US including anticholinergic agents [darifenacin, fesoterodine, oxbutynin, solifenacin, tolterodine and trospium] and beta-3 adrenergic receptor agonists [mirabegron and vibegron] including clinical efficacy, safety, and costs; no mention of ALT elevations or hepatotoxicity of any of the agent discussed). 36897601

## OTHER REFERENCE LINKS

1 Recent References on Vibegron: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Vibegron/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Vibegron: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vibegron)